# Beta-2 Adrenergic Agonists

## OVERVIEW

### Introduction

The beta-2 adrenergic agonists are a large group of drugs that mimic the actions of naturally occurring catecholamines such as norepinephrine, epinephrine and dopamine. Direct agonists directly interact with the adrenergic receptors, whereas indirect agonists typically stimulate the release of endogenous catecholamines. The beta-2 adrenergic agonists act mainly on the smooth muscle of the vasculature, bronchial tree, intestines and uterus. These agents also act on the liver stimulating glycogenolysis and release of glucose from the liver and muscle (particularly if used in high doses). The beta-2 adrenergic agonists are used largely as bronchodilators in the management of asthma, both in control of acute symptomatic attacks as well as chronic, long term prevention and management. These agents are some of the most commonly prescribed drugs for asthma and are widely used and proven to be well tolerated and safe. The use of beta adrenergic agonists in asthma has not been associated with elevations in serum aminotransferase or alkaline phosphatase levels or in causing clinically apparent liver disease. When given in large doses or after intentional overdose, beta adrenergic agonists can cause liver injury. Most case reports of liver damage from these agents have been associated with their use in control of premature labor (for their effects on relaxation of uterine smooth muscle). The liver injury typically arises within a few days of starting high dose intravenous beta adrenergic agonists, is usually asymptomatic, not associated with jaundice, and rapidly reversed once the medication is stopped.

Commonly used beta adrenergic drugs include albuterol, bitolterol, metaproterenol, pirbuterol, salmeterol and terbutaline. These agents share structural similarity and are discussed together.

### Beta Adrenergic Agonists Used for Asthma: Bitolterol, Formoterol, Metaproterenol, Pirbuterol, Salbutamol (Albuterol), Salmeterol, Terbutaline

The beta adrenergic agonists act on bronchial smooth muscle inducing bronchodilation and relieving bronchospasm in asthma and chronic obstructive pulmonary disease with asthmatic features. Their use in asthma has not been associated with liver injury.

#### Background

The beta adrenergic agonists are potent bronchodilators that are widely used in the management of bronchial asthma. These agents act by engaging the beta-2 adrenergic receptors on smooth muscle of bronchial tissue, relieving bronchospasm and reducing airway resistance. They also act on smooth muscle of the vascular system, intestines and uterus. Common forms of beta adrenergic agonists include albuterol, bitolterol, fenoterol, formoterol, levalbuterol, metaproterenol, salmeterol, pirbuterol and terbutaline, which all have similar mechanisms of action, chemical structure, side effects and efficacy, but somewhat different pharmacokinetics allowing for differences in dosing regimens and duration of action. Most of these agents are administered by inhalation (alone or in combination with other bronchodilators or corticosteroids), with only albuterol and terbutaline being available in oral forms in the United States. Albuterol (also known as salbutamol) is available in generic forms and under the brand names of Proventil and Ventolin as 2 and 4 mg tablets as well as in aerosol and syrup solutions. The recommended regimen of albuterol is 2 to 4 mg orally 3 to 4 times a day. Sustained release formulations are available for twice daily dosing (4 and 8 mg). Salmeterol is available as an inhalation powder in generic forms and under the brand name of Serevent Diskus. The typical dosage is one inhalation (50 mcg) twice daily and it is recommended to be given with corticosteroids only. Systemic absorption is minimal. Terbutaline is available in generic forms and under the brand name of Brethine in tablets of 2.5 and 5 mg, the usual adult dosage being 5 mg three times daily. These oral forms of beta adrenergic agonists are approved as means of prevention and reversal of bronchospasm and are used largely in the therapy of asthma. Terbutaline is also available in parenteral formulations for use in acute bronchospasm and has also been used as therapy of premature labor. Common side effects of the beta adrenergic agonists include dizziness, headache, nervousness, tachycardia, palpitations, nausea and diaphoresis, largely due to their beta adrenergic effects on other organs. Rare, potentially severe adverse events include cardiovascular events, paradoxical worsening of asthma and acute hypersensitivity reactions.

#### Hepatotoxicity

Prospective studies have shown that ALT elevations occur in less than 1% of patients receiving long term oral therapy with typical beta adrenergic bronchodilators, but instances of clinically apparent liver injury have not been reported in any detail. However, several cases of acute elevations in serum aminotransferase levels have been described in pregnant women receiving high doses of beta adrenergic agents intravenously for prevention or control of premature labor (Case 1). Serum alkaline phosphatase, GGT and bilirubin levels are generally normal or within the normal range for later stages of pregnancy. The serum aminotransferase elevations are usually asymptomatic, but may be associated with nausea and right upper quadrant pain. Bilirubin elevations are minimal and cases with jaundice have not been reported. The abnormalities resolve promptly (within 1 to 3 weeks) upon stopping therapy and have not been associated with fatalities or chronic liver injury.

Likelihood score, oral beta-adrenergic agonists: E (unlikely cause of clinically apparent liver injury).

Likelihood score, intravenous terbutaline: C[H] (high doses of intravenous terbutaline are a probable cause of acute serum aminotransferase elevations that can be symptomatic and clinically apparent).

#### Mechanism of Hepatotoxicity

The mechanism of hepatic injury due to beta adrenergic agents is probably a direct hepatotoxicity associated with high dose, particularly intravenous, therapy.

#### Outcome and Management

Typically, liver enzyme abnormalities resolve rapidly after stopping beta adrenergic agents. No cases of fulminant hepatitis or chronic liver injury have been convincingly linked to use of these agents. The hepatotoxicity associated with high dose therapy is rapidly reversed and cases of recurrence upon reexposure to typical oral doses have not been reported.

Drug Class: Antiasthmatic Agents, Beta-2 Adrenergic Agonists

## CASE REPORT

### Case 1. Serum aminotransferase elevations during intravenous terbutaline therapy of premature labor.

[Modified from: Quinn PG, Sherman BW, Tavill AS, Gibas AL. Terbutaline hepatitis in pregnancy: report of two cases and literature review. Am J Gastroenterol 1994; 89: 781-4. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/8172156)]

A 34 year old woman developed premature labor during her 26th week of pregnancy and was treated with intravenous terbutaline. Approximately 5 weeks later, she was admitted with generalized pruritus and found to have marked elevations in serum aminotransferase levels (ALT 223, AST 129), but normal alkaline phosphatase levels for pregnancy and no jaundice (bilirubin 0.4 mg/dL). An ultrasound showed a normal liver and biliary tree. Tests for hepatitis A, B and C were negative as were autoantibodies. The pruritus and liver test abnormalities were initially attributed to cholestasis of pregnancy, but rising ALT levels (Table) led to a tentative diagnosis of terbutaline induced hepatotoxicity. Terbutaline was stopped and serum aminotransferase levels promptly declined. However, uterine contractions increased and the patient delivered 3 healthy babies 3 days later. In follow up 3 weeks after delivery, serum aminotransferase levels were normal.

#### Key Points

Medication: | Terbutaline (intravenous, ~3 mg/day)
Pattern: | Hepatocellular (ALT elevations only)
Severity: | 1+ (aminotransferase elevations without jaundice)
Latency: | 5 weeks (elevated ALT)
Recovery: | <3 weeks
Other medications: | Ampicillin, cholestyramine, hydoxyzine, aspirin, docusate, ferrous sulfate, prednisone (10 mg/day)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Terbutaline pump started at 26 weeks of gestation.
39 days | | 223 | 267 | 0.4
40 days | | 350
41 days | | 620
42 days | | 710
44 days | | 2011 | 308 | 0.4
45 days | | 1073
47 days | | 950 | | | Pruritus
50 days | | 1320
51 days | 0 | 920 | | | Terbutaline stopped
53 days | 2 days | 710
54 days | 3 days | 180 | | | Caesarean delivery
10 weeks | 3 weeks | 20
Normal Values | | <56 | | <1.2

* Values estimated from Figure 1, Patient 2.

#### Comment

The differential diagnosis of liver disease during pregnancy is challenging and includes viral hepatitis, cholestasis of pregnancy, acute fatty liver of pregnancy and drug induced liver disease. This patient was initially thought to have cholestasis of pregnancy with itching and abnormal serum enzyme elevations. However, the height of the ALT elevations with normal alkaline phosphatase levels and bilirubin were atypical of cholestasis of pregnancy and the role of terbutaline was considered. Acute fatty liver of pregnancy was excluded by the normal ultrasound. Stopping terbutaline led to a prompt decrease in ALT levels, but also triggered premature labor and delivery. The absence of bilirubin and alkaline phosphatase elevations supported the role of terbutaline induced liver injury in this patient. Asymptomatic but prominent elevations in serum aminotransferase levels have been reported with use of high doses of beta adrenergic agents in pregnant women.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Albuterol – Salbutamol, Proventil® HFA

Salmeterol – Serevent®

Terbutaline – Brethine®

DRUG CLASS

Antiasthmatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=terbutaline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Albuterol Sulfate | 51022-70-9 | C13-H21-N-O3.1/2H2-O4-S | Albuterol Sulfate Chemical Structure
Salmeterol Xinafoate | 94749-08-3 | C25-H37-N-O4.C11-H8-O3 | Salmeterol Xinafoate Chemical Structure
Terbutaline Sulfate | 23031-32-5 | C12-H19-N-O3.1/2H2-O4-S | Terbutaline Sulfate Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 September 2017

Zimmerman HJ. Adrenergic agents used as tocolytic (uterine relaxing) drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 715. (Expert review of liver injury published in 1999, mentions that at least 3 cases of acute hepatocellular injury have been described after use of terbutaline to arrest premature labor).
Westfall TC, Westfall DP. Adrenergic agonists and antagonists. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 277-333. (Textbook of pharmacology and therapeutics).
Suzuki M, Inagaki K, Kihira M, Matsuzawa K, Ishikawa K, Ishizuka T. Maternal liver impairment associated with prolonged high-dose administration of terbutaline for premature labor. Obstet Gynecol 1985; 66 (3 Suppl): 14S-15S. (32 year old pregnant woman with premature labor was treated with iv terbutaline and developed nausea and enzyme elevations [bilirubin 0.7 mg/dL, ALT 1000 U/L, Alk P 172 U/L] 1 week later, which fell to normal 2 weeks after stopping and 1 week after delivery). 4022509
Wilczyński J, Hauk-Szklarek E, Borowski P, Wysocki K, Kuydowicz J, Sałacińska B. [Increased activity of aminotransferases (ALAT, AspAT) in pregnant women threatened with immature and premature delivery treated with fenoterol] Ginekol Pol 1993; 64: 117-9. Polish. 835973
Quinn PG, Sherman BW, Tavill AS, Gibas AL. Terbutaline hepatitis in pregnancy: report of two cases and literature review. Am J Gastroenterol 1994; 89: 781-4. (33 and 34 year old pregnant women developed marked ALT elevations [peaking at 910 and 2011 U/L] without jaundice after 4 weeks of terbutaline therapy [oral and iv], resolving within 3-4 days of stopping to near normal levels, whereupon delivery occurred: Case 1). 8172156
Fontaine P, Géhénot M, Goffin P, Horsmans Y. Fenoterol-induced hepatitis in a pregnant woman: a case report. Am J Obstet Gynecol 1996; 174: 1647-8. (27 year old woman developed acute elevations in ALT [peak 12 times ULN] with normal GGT and bilirubin levels during high dose fenoterol therapy for premature labor, resolving within 2 weeks of stopping fenoterol). 9065147
Edelman JM, Turpin JA, Bronsky EA, Grossman J, Kemp JP, Ghannam AF, DeLucca PT, at al. Oral montelukast compared with inhaled salmeterol to prevent exercise-induced bronchoconstriction. A randomized, double-blind trial. Exercise Study Group. Ann Intern Med 2000;132: 97-104. (191 patients with exercise induced bronchospasm received either montelukast or salmeterol aerosol for 8 weeks; in discussion of safety there was no mention of liver side effects or ALT levels). 10644288
Ibanez I, Perez E, Vidal X, Laporte JR. Prospective surveillance of acute serious liver disease unrelated to infectious, obstructive, or metabolic diseases: epidemiological and clinical features, and exposure to drugs. J Hepatol 2002; 37: 592-600. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/(Prospective%20study%20of%20acute%20serious%20liver%20disease%20over%206%20years%20found%20107%20cases%20of%20dili,%20salbutamol%20[terbutaline]%20listed%20as%20cause%20of%206%20cases).%3C/em%3E%3C/h3%3E%3C/li%3E%3Cli%3E%3Ch3%3E%20Sabat%C3%A9%20M,%20Ib%C3%A1%C3%B1ez%20L,%20P%C3%A9rez%20E,%20et%20al.%20Risk%20of%20acute%20liver%20injury%20associated%20with%20the%20use%20of%20drugs:%20a%20multicentre%20population%20survey.%20Aliment%20Pharmacol%20Ther%202007;%2025:%201401-9.%20%3Ca%20href=) (Prospective study of acute serious liver disease occurring over 6 years in Catalonia, Spain found 107 cases of drug induced liver injury, 3 of which were attributed to salbutamol [albuterol], but no clinical details given).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to albuterol or terbutaline or other oral or inhalational beta adrenergic agonists). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Terbutaline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Terbutaline/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Terbutaline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Terbutaline)